# Lenvatinib

## OVERVIEW

### Introduction

Lenvatinib is orally available multi-kinase inhibitor and antineoplastic agent that is used in treatment of advanced, metastatic medullary thyroid cancer and refractory renal cell carcinoma. Lenvatinib is associated with a modest rate of serum enzyme elevations during treatment and has been implicated to rare instances of clinically apparent, acute liver injury some of which have been fatal.

### Background

Lenvatinib (len va' ti nib) is an orally available, small molecule, multi-kinase inhibitor with activity against vascular endothelial growth factor receptor (VEGFR) 1, 2 and 3 as well as fibroblast growth factor (FGF) 1, 2, 3 and 4, platelet derived growth factor receptor (PDGFR) alpha, cKit and the RET proto-oncogene. Several of these receptors are overexpressed in cancer cells and can cause unregulated cell growth. Lenvatinib has been evaluated as therapy of several forms of advanced and metastatic carcinomas and has shown efficacy in thyroid and renal cell carcinoma. Lenvatinib received accelerated approval for use in the United States in 2015 for therapy of metastatic, refractory thyroid cancer after failure of other therapies. Indications were expanded in 2016 to include advanced, refractory renal cell carcinoma. Lenvatinib is available as capsules of 4 and 10 mg under the brand name Lenvima. The recommended dose for thyroid cancer is 24 mg orally once daily and for renal cell cancer is 18 mg (in combination with 5 mg of everolimus) orally once daily. Side effects are common and can include hypertension, fatigue, diarrhea, nausea, vomiting, anorexia, weight loss, abdominal pain, stomatitis, headache, joint and muscle pain, peripheral edema, cough, dyspnea, rash, hemorrhagic events and proteinuria. Other uncommon, but potentially severe side effects include severe hypertension, heart failure, arterial thrombotic events, proteinuria, severe diarrhea, renal impairment, gastrointestinal perforation or fistulae, prolongation of the QTc interval, hypocalcemia, reversible posterior leukoencephalopathy and embryo-fetal toxicity.

### Hepatotoxicity

In large clinical trials of lenvatinib, elevations in serum aminotransferase levels were common, occurring in 52% of patients. Values greater than 5 times the upper limit of normal (ULN), however, occurred in only 3% to 5% of recipients. Serum alkaline phosphatase elevations were also common occurring in 28% of patients and were above 3 times ULN in 2%. In addition, fatal hepatic failure was reported in 3 of 1160 patients treated in preregistration clinical trials and another patient developed symptomatic but self-limited acute hepatitis with jaundice. The degree of relatedness of these events to lenvatinib therapy, however, was not defined. In the product label for lenvatinib, serum ALT, AST and alkaline phosphatase elevations are listed as adverse reactions, and acute hepatitis is mentioned as a rare occurrence. Monitoring of serum enzymes before, every 2 weeks for 2 months and monthly thereafter during treatment is recommended with dose reduction or discontinuation depending upon the degree and persistence of the abnormalities.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury accounting for serum enzyme elevations during lenvatinib therapy is not known, but injury may be a direct effect of inhibition of cellular kinases by this multi-specific tyrosine kinase inhibitor. Lenvatinib is metabolized in the liver, predominantly by the cytochrome P 450 system and specially by CYP 3A4. Nevertheless, lenvatinib is not significantly affected by CYP 3A4 inducers or inhibitors or to cause clinically relevant drug-drug interactions.

### Outcome and Management

Routine monitoring of liver tests before and periodically throughout treatment with lenvatinib is recommended. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Clinically apparent liver injury should prompt immediate interruption of lenvatinib therapy. There is little information on cross reactivity in risk for hepatic injury between lenvatinib and other protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Related Drugs: Everolimus

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lenvatinib – Lenvima®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Lenvatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lenvatinib | 417716-92-8 | C21-H19-Cl-N4-O4 | Lenvatinib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors such as lenvatinib).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents including the kinase inhibitors gefitinib, erlotinib and crizotinib; lenvatinib is not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Boss DS, Glen H, Beijnen JH, Keesen M, Morrison R, Tait B, Copalu W, et al. A phase I study of E7080, a multitargeted tyrosine kinase inhibitor, in patients with advanced solid tumours. Br J Cancer 2012; 106: 1598-604. (Among 82 patients with various forms of advanced cancer who received escalating doses of lenvatinib, objective responses occurred in 7 patients [9%] including 4 of 9 with renal cell cancer, while adverse events included hypertension, diarrhea, nausea, vomiting and stomatitis; no mention of ALT elevations or hepatotoxicity). 22516948
Molina AM, Hutson TE, Larkin J, Gold AM, Wood K, Carter D, Motzer R, et al. A phase 1b clinical trial of the multi-targeted tyrosine kinase inhibitor lenvatinib (E7080) in combination with everolimus for treatment of metastatic renal cell carcinoma (RCC). Cancer Chemother Pharmacol 2014; 73: 181-9. (Among 27 patients with metastatic, refractory renal cell cancer treated with lenvatinib and everolimus, objective responses occurred in 6 [33%] and adverse events were common; no mention of ALT elevations or hepatotoxicity). 24190702
Cabanillas ME, Schlumberger M, Jarzab B, Martins RG, Pacini F, Robinson B, McCaffrey JC, et al. A phase 2 trial of lenvatinib (E7080) in advanced, progressive, radioiodine-refractory, differentiated thyroid cancer: A clinical outcomes and biomarker assessment. Cancer 2015; 121: 2749-56. (Among 58 patients with advanced refractory thyroid cancer treated with lenvatinib [24 mg daily], the objective response rate was 50%, but adverse events were common with more than half developing hypertension, weight loss, diarrhea, proteinuria, fatigue and anorexia; no mention of ALT elevations or hepatotoxicity). 25913680
Schlumberger M, Tahara M, Wirth LJ, Robinson B, Brose MS, Elisei R, Habra MA, et al. Lenvatinib versus placebo in radioiodine-refractory thyroid cancer. N Engl J Med 2015; 372: 621-30. (Among 261 patients with progressive and refractory thyroid cancer treated with lenvatinib [24 mg daily] or placebo, median progression free survival was improved by lenvatinib [18.3 vs 3.6 months], although side effects were frequent and sometimes severe; liver failure was report in 0.4% of recipients). 25671254
Lenvatinib (Lenvima) for thyroid cancer. Med Lett Drugs Ther 2015; 57 (1475): e120-1. (Concise review of the mechanism of action, clinical efficacy, safety and costs of lenvatinib shortly after its approval for use in advanced, refractory thyroid cancer; mentions that side effects led to dose reductions in 68% of patients and discontinuation in 18%, and that adverse events included hepatotoxicity and fatal hepatic failure). 26262885

## OTHER REFERENCE LINKS

1. Recent References on Lenvatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lenvatinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lenvatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lenvatinib)